# Mercaptopurine

## OVERVIEW

### Introduction

Mercaptopurine (also referred to as 6-mercaptopurine or 6-MP) is a purine analogue that is effective both as an anticancer and an immunosuppressive agent, and is used to treat leukemia and autoimmune diseases as a corticosteroid-sparing agent. Mercaptopurine therapy is associated with a high rate of serum aminotransferase elevations which can be accompanied by jaundice. In addition, mercaptopurine has been linked to instances of clinically apparent acute liver injury and long term therapy to nodular regenerative hyperplasia.

### Background

Mercaptopurine (mer kap" toe pure' een) is a purine analogue that acts as an antimetabolite by antagonism of purine metabolism which results in a general inhibition of DNA, RNA and subsequent protein synthesis. Mercaptopurine also has antiinflammatory and immunosuppressive activity, inhibiting the maturation of T cells and blocking delayed hypersensitivity reactions. Mercaptopurine was introduced into use in the 1950s for the therapy of leukemia and lymphoma and was formally approved for use in the United States in 1953. It is still used in therapy of acute lymphocytic leukemia and off-label for autoimmune conditions such as Crohn’s disease. Mercaptopurine is available generically and under the brand name of Purinethol as tablets of 50 mg. The usual dose is 1 to 3 mg per kilogram or 50 to 150 mg daily, and it is typically given long term. Common side effects include nausea, abdominal upset, rash, aphthous ulcers and dose related bone marrow suppression.

### Hepatotoxicity

Mercaptopurine has been associated with several forms of hepatotoxicity. Patients receiving mercaptopurine for leukemia often have transient and asymptomatic rises in serum aminotransferase or alkaline phosphatase levels and a proportion of these patients develop jaundice, particularly when it is given in high doses. In case series of patients with autoimmune diseases (such as inflammatory bowel disease) treated with mercaptopurine, up to 30% developed serum aminotransferase elevations and these can be persistent as long as therapy is continued, resolving either with dose reduction or discontinuation. Liver biopsy usually demonstrates steatosis and centrolobular injury with scant inflammation.

Mercaptopurine can also lead to a distinctive acute, clinically apparent liver injury that usually presents with fatigue and jaundice and a cholestatic or mixed pattern of serum enzyme elevations 1 to 6 months after starting therapy, but sometimes later, particularly following an increase in dose. Serum enzyme levels are often not very high, certainly not in the range that occurs with acute viral hepatitis. Rash, fever and eosinophilia are uncommon and autoantibodies are generally not found. Liver biopsy typically shows a mixed hepatocellular-cholestatic injury with cholestasis, focal hepatocellular necrosis, bile duct injury and variable amounts of inflammation. The injury is idiosyncratic and similar to the cholestatic hepatitis associated with azathioprine. The liver injury usually resolves upon stopping, but prolonged cholestasis has been reported and some cases have been fatal. In large case series and registries, mercaptopurine usually ranks among the top 20 causes of drug induced liver injury, and if combined with cases due to azathioprine [a prodrug of mercaptopurine] would rank among the top 10 more frequent causes.

Chronic therapy with mercaptopurine and other thiopurines can lead to nodular regeneration and symptomatic portal hypertension. This chronic hepatotoxicity typically presents with fatigue and signs and symptoms of portal hypertension (ascites, varices), with mild liver enzyme abnormalities and minimal jaundice arising 6 months to many years after starting mercaptopurine. Liver biopsy shows nodular regenerative hyperplasia without significant fibrosis and varying amounts of sinusoidal dilation and central vein injury. This syndrome can progress to hepatic failure, particularly if mercaptopurine is continued, but gradual improvement on stopping therapy is typical. Rarely, the onset of this syndrome can be acute with abdominal pain and ascites in which situation liver biopsy usually shows sinusoidal dilation, central congestion and injury to sinusoidal endothelial cells suggestive of veno-occlusive disease, which is currently referred to as sinusoidal obstructive syndrome. Typically, serum aminotransferase levels and alkaline phosphatase levels are minimally elevated, even in the presence of hyperbilirubinemia and other manifestations of hepatic dysfunction and portal hypertension. Many cases present initially with unexplained thrombocytopenia, and progressive decreases in platelet counts may be the most sensitive marker for the development of the non-cirrhotic portal hypertension.

Finally long-term therapy with mercaptopurine and other thiopurines has been implicated in leading to the development of malignancies, including hepatocellular carcinoma (HCC) and hepatosplenic T cell lymphoma (HSTCL). Both of these complications are rare but have been reported in several dozen case reports and small case series. In neither instance, has the role of thiopurine therapy in causing the malignancies been proven, and similar cases have been described in patients with autoimmune conditions or after solid organ transplantation who have not received thiopurines. Hepatocellular carcinoma typically arises after years of azathioprine or mercaptopurine therapy and in the absence of accompanying liver disease (although sometimes with focal hepatic glycogenosis). The HCC is most frequently found on an imaging study done of an unrelated condition. The prognosis is more favorable than that of HCC associated with cirrhosis. Hepatosplenic T cell lymphoma has been reported largely among young men with inflammatory bowel disease and long term immunosuppression with a thiopurine with or without anti-tumor necrosis factor therapy. The typical presentation is with fatigue, fever, hepatosplenomegaly and pancytopenia. The diagnosis is made by bone marrow or liver biopsy showing marked infiltration with malignant T cells. HSTCL is poorly responsive to antineoplastic therapy and has a high mortality rate.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

Mercaptopurine is believed to have a direct, dose related hepatotoxic effect and similar types of injury can be reproduced in animal models. Mercaptopurine undergoes extensive hepatic metabolism to other thiopurines via several pathways. The active metabolite is 6-thioguanine nucleotide (6-TGN) which is generated by a multistep process involving phosphoribosyl transferases and kinases. The toxic effects of mercaptopurine, and particularly the myelotoxicity, have been linked to production of higher levels of methylmercaptopurine nucleotides (MMPN) generated by methyltransferases. Bone marrow toxicity is typically accompanied by high levels of MMPN and modest or low levels of 6-TGN. Determinants of the balance of the pathways to production of these two metabolites are partially genetic but are clearly affected by other factors including concomitant medications and concurrent medical conditions. The balance of these thiopurine metabolites appears to play less of a role in hepatotoxicity and particularly the cholestatic hepatitis caused by mercaptopurine and azathioprine. The cholestatic hepatitis is more likely due to an idiosyncratic reaction perhaps in response to an immunogenic intermediate of their metabolism. The similarity of the thiopurine induced cholestasis to the idiopathic cholestasis of pregnancy raises the possibility of interference with biliary transporters. Finally, the cause of nodular regenerative hyperplasia with long-term thiopurine injury is probably due to another mechanism, possibly chronic vascular injury to the liver.

### Outcome and Management

The acute liver injury caused by mercaptopurine usually begins to improve rapidly upon stopping the medication, but instances of progression to hepatic failure despite discontinuation of mercaptopurine have been reported. There are no known specific treatments for mercaptopurine hepatotoxicity. Rechallenge with mercaptopurine usually results in recurrence of the injury (within days to weeks) and should be avoided. Some, but not all, patients have tolerated switching therapy to azathioprine or thioguanine or with use of lower doses in combination with allopurinol. In cases of severe hepatic injury from mercaptopurine, however, substitution with a structurally unrelated antimetabolite or immunosuppressive agent is more appropriate.

Drug Class: Antineoplastic Agents, Antimetabolites; Gastrointestinal Agents

Other Drugs in the Subclass, Purine Analogues: Azathioprine, Cladribine, Clofarabine, Fludarabine, Nelarabine, Pentostatin, Thioguanine

See also: Transplant Drugs

Other Drugs in the Subclass, Purine Analogues/Thiopurines: Azathioprine, Thioguanine

## CASE REPORT

### Case 1. Acute cholestatic hepatitis due to mercaptopurine.(1)

A 45 year old man with membranous glomerulonephritis developed nausea and fatigue followed by jaundice 4 months after adding mercaptopurine (150 to 200 mg/day) to chronic prednisolone therapy. He had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. Physical examination revealed jaundice, enlargement of the liver and spleen and peripheral edema. He also had Cushingoid features. Laboratory testing showed total bilirubin of 9.9 mg/dL (direct 5.9 mg/dL), AST 112 and alkaline phosphatase 11.3 Bodansky units (2.5 times ULN). Mercaptopurine was stopped and he improved clinically within a week, while laboratory abnormalities decreased more slowly (Table). Two months later all liver tests were normal.

#### Key Points

Medication: | Mercaptopurine (200 mg daily)
Pattern: | Cholestatic (R=1.1)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 months
Recovery: | 2 months
Other medications: | Prednisolone, furosemide which were continued

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (BU/L) | Bilirubin mg/dL) | Other
0 | Pre | 14 | 3.5
18 weeks | 0 | 112 | 11.3 | 9.9 | Admission
| 4 days | 86 | 14.4 | 11.6
19 weeks | 1 week | | 19.2 | 7.0
23 weeks | 5 weeks | 22 | 11.9 | 0.2
6 months | 9 weeks | | 4.6
Normal Values | | <40 | <4.5 | <1.2

#### Comment

A typical cholestatic hepatitis due to mercaptopurine arising after 4 months of therapy with mild symptoms, prominent jaundice, and only mild-to-moderate elevations in serum enzymes. Jaundice resolved within a month, while the serum alkaline phosphatase elevations persisted for longer.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mercaptopurine – Generic, Purinethol®

DRUG CLASS

Antineoplastic Agents

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mercaptopurine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mercaptopurine | 6112-76-1 | C5-H4-N4-S.H2-O

## CITED REFERENCES

1 Shorey J, Schenker S, Suki WN, Combes B. Hepatotoxicity of mercaptopurine. Arch Intern Med 1968; 122: 54-8. 5659378

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2026

Abbreviations used: TPMT, thiopurine methyltransferase; HSTCL, hepatosplenic T-cell lymphoma; HCC, hepatocellular carcinoma; MMPN, methylmercaptopurine nucleotides; 6-TGN, 6-thioguanine nucleotides; ICP, idiopathic cholestasis of pregnancy; ALL, acute lymphocytic leukemia.

Zimmerman HJ. Antipurines. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 687-9. (Expert review of hepatotoxicity of thiopurines published in 1999).
DeLeve LD. Thiopurines. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 555-6. (Review of hepatotoxicity of thiopurines).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Purine analogues. Cytotoxic agents. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1184-6. (Textbook of pharmacology and therapeutics; mercaptopurine nucleotides inhibit de novo purine synthesis and become incorporated into nucleic acids).
Farber S. Summary of experience with 6-mercaptopurine. Ann N Y Acad Sci 1954; 60: 412-4. (Initial experience in treating 80 children with malignancies using mercaptopurine; 6 cases of jaundice; "Liver function tests inconclusive. Icterus cleared when 6-MP omitted"). 14350545
Philips FS, Sternberg SS, Hamilton S, Clarke DA. The toxic effects of 6-mercaptopurine and related compounds. Ann N Y Acad Sci 1954; 60: 283-96. (Toxicity studies in laboratory animals). 14350534
Ellison RR, Silver RT, Engle RL Jr. Comparative study of 6-chloropurine and 6-mercaptopurine in acute leukemia in adults. Ann Intern Med 1959: 322-38. (Among 18 patients with leukemia treated with mercaptopurine and 16 with chloropurine, jaundice occurred in 6 in each group, arising 18-153 days after starting drug, but few details given and most had septicemia and hepatic leukemic infiltrates). 13820065
McIlvanie SK, MacCarthy JD. Hepatitis in association with prolonged 6-mercaptopurine therapy. Blood 1959; 14: 80-90. (Four cases of acute "toxic" liver injury during mercaptopurine therapy of leukemia in children, ages 4-13 years, arising 2-6 months after starting drug [bilirubin 4.5-8.7 mg/dL, Alk P mildly elevated]). 13607581
Clark PA, Hsia YE, Huntsman RG. Toxic complications of treatment with 6-mercaptopurine: two cases with hepatic necrosis and intestinal ulceration. Br Med J 1960; 1: 393-5. (Two cases; 5 year old boy with acute leukemia developed jaundice 7 weeks after starting mercaptopurine [bilirubin 6.6 mg/dL, minimal Alk P elevations], on autopsy liver showed severe centrolobular hepatic necrosis; 40 year old man with acute leukemia developed jaundice 4 weeks after starting mercaptopurine [bilirubin 9.5 mg/mL, ALT 140 U/L, Alk P 2 times ULN], with rapid progress and death, autopsy showing centrilobular necrosis). 13810473
Einhorn M, Davidsohn I. Hepatotoxicity of mercaptopurine. JAMA 1964; 188: 802-6. (Among 38 patients with leukemia treated with mercaptopurine, 16 developed jaundice, resolving with stopping in half and recurring in two with rechallenge; onset in 4-8 weeks [bilirubin 3.6-14.8 mg/dL, ALT 21-140 U/L, Alk P 1-6 times ULN]). 14132534
Mackay IR, Weiden S, Ungar B. Treatment of chronic active hepatitis and lupoid hepatitis with 6-mercaptopurine and azathioprine. Lancet 1964; 1: 899-902. (Experience in using mercaptopurine and azathioprine in 5 patients with autoimmune hepatitis, mentions that hyperbilirubinemia was a side effect of higher doses, resolving with dose modification). 14124080
Corley CC Jr, Lessner HE, Larsen WE. Azathioprine therapy of "autoimmune" diseases. Am J Med 1966; 41: 404-12. (Experience in using azathioprine in 46 patients with various autoimmune diseases, mostly an idiopathic thrombocytopenic purpura and lupus erythematosus; side effects including nausea and vomiting occurred with higher doses, mild cytopenias were common, and one patient had jaundice after 6 months [350 mg/day] [bilirubin 3.8 mg/L, mild Alk P and ALT elevations], biopsy showing cholestasis). 5330635
Krawitt EL, Stein JH, Kirkendall WM, Clifton JA. Mercaptopurine hepatotoxicity in a patient with chronic active hepatitis. Arch Intern Med. 1967; 120: 729-34. (18 year old girl with autoimmune hepatitis poorly controlled on prednisone developed fatigue and jaundice within 2-3 weeks of starting mercaptopurine, with worsening hepatic function, multiorgan failure and death). 4168362
Shorey J, Schenker S, Suki WN, Combes B. Hepatotoxicity of mercaptopurine. Arch Intern Med 1968; 122: 54-8. (Two cases; 45 year old man developed malaise and jaundice 4 months after starting mercaptopurine for glomerulonephritis [bilirubin 9.9 mg/dL, AST 112 U/L, Alk P 3 times ULN], resolving within 6 weeks of stopping; 39 year old woman developed jaundice 2-3 months after starting mercaptopurine [bilirubin 16.4 mg/dL, AST 314 U/L, Alk P 4 times ULN], with sudden unexplained death shortly after, autopsy showing intrahepatic cholestasis with scant necrosis). 5659378
Lascari AD, Givier RL, Saper RT, Hill LF. Portal hypertension in a case of acute leukemia treated with antimetabolites for 10 years. N Engl J Med 1968; 279: 303-6. (6 year old girl with acute leukemia and long term chemotherapy including mercaptopurine developed splenomegaly after 3 years, with subsequent recurrent variceal hemorrhage; splenectomy and porto-caval shunt yielded excellent outcome; biopsy showing fibrosis without cirrhosis). 5301748
Robert J, Barbier P, Manaster J, Jacobs E. Hepatotoxicity of cytostatic drugs evaluated by liver function tests and appearance of jaundice. Digestion 1968; 1: 229-32. (Analysis of 417 courses of cytostatic therapy with various agents; half of patients receiving mercaptopurine developed elevations in serum bilirubin, but no specifics given). 5696244
Sparberg M, Simon N, Del Greco F. Intrahepatic cholestasis due to azathioprine. Gastroenterology 1969; 57: 439-41. (44 year old man developed jaundice 13 months after renal transplant [bilirubin 21 mg/dL, ALT 94 U/L, Alk P normal], biopsy showing cholestasis without hepatocyte necrosis; patient died after withdrawal of azathioprine and increase in corticosteroids). 4951148
Lehmann GW. [Intrahepatic cholestasis caused by 6-mercaptopurine]. Kinderarztl Prax 1969; 37: 506-11. German. PMID: 5379242 (15 year old girl with acute leukemia developed nausea followed by jaundice 2 months after starting mercaptopurine [bilirubin 10.6 rising to 38.1 mg/dL, ALT 42 U/L, Alk P ~2 times ULN, eosinophils 15%], ultimately responding to prednisolone, but subsequent relapse of leukemia).
Drinkard JP, Stanley TM, Dornfeld L, Austin RC, Barnett EV, Pearson CM, Vernier RL, et al. Azathioprine and prednisone in the treatment of adults with lupus nephritis. Medicine (Baltimore) 1970; 49: 411-32. (Report on 20 patients with lupus nephritis treated with combination of prednisone and azathioprine; hepatotoxicity occurred in one patient developing jaundice at 11 months [bilirubin 11.4 mg/dL, ALT 80 U/L and Alk P ~1.5 times ULN], resolving with stopping). 4924695
Malekzadeh MH, Grushkin CM, Wright HT Jr, Fine RN. Hepatic dysfunction after renal transplantation in children. J Pediatr 1972; 81: 279-85. (Nine of 63 children with renal transplants had evidence of liver disease, 8 considered due to azathioprine, arising 3 to 30 months after transplant [bilirubin 1.2-24 mg/dL, ALT 116-500 U/L, Alk P 1-10 times elevated], improving on stopping). 4339534
Zarday A, Veith FJ, Gliedman ML, Soberman R. Irreversible liver damage after azathioprine. JAMA 1972; 222: 690-1. (27 year old woman developed chronic liver disease after renal transplantation, improving on stopping azathioprine but then progressing to end stage liver disease; in retrospect, possibly due to hepatitis C). 4562099
Millard PR, Herbertson BM, Evans DB, Calne RY. Azathioprine hepatotoxicity in renal transplantation. Transplantation 1973; 16: 527-30. Not in PubMed (Complex analysis of patients after renal transplantation finding no correlation between changes in azathioprine dose and changes in ALT levels).
Briggs WA, Lazarus JM, Birtch AG, Hampers CL, Hager EB, Merrill JP. Hepatitis affecting hemodialysis and transplant patients. Arch Intern Med 1973; 132: 21-8. (Analysis of 14 patients who developed hepatitis B while on renal dialysis and 14 after renal transplant; reinstitution of azathioprine was often associated with exacerbation of the hepatitis). 4577389
Ireland P, Rashid A, von Lichtenberg F, Cavallo T, Merrill JP. Liver disease in kidney transplant patients receiving azathioprine. Arch Intern Med 1973; 132: 29-37. (Analysis of course of liver disease in 24 kidney transplant patients suggested that azathioprine had little or no effect on course of what was likely chronic viral hepatitis in transplant patients). 4577390
Koretz RL. Azathioprine in liver disease. Arch Intern Med 1974; 133: 870-1. Replies by authors. PMID: 4595401 (Letter in response to Briggs [1973] and Ireland [1973] pointing out that the patients were from the same institution and may have been the same in the two studies, but that conclusions regarding safety of azathioprine were different).
Du Vivier A, Munro DD, Verbov J. Treatment of psoriasis with azathioprine. Br Med J 1974; 1: 49-51. (Among 29 patients with psoriasis treated with azathioprine, 2 developed cholestasis and 8 portal fibrosis as shown by liver biopsies performed before, at 6 months and then annually). 4812392
Berne TV, Chatterjee SN, Craig JR, Payne JE. Hepatic dysfunction in recipients of renal allografts. Surg Gynecol Obstet 1975; 141: 171-5. (Among 142 patients undergoing renal transplantation, 18 developed liver disease, all while on azathioprine; in 10 patients there was improvement with stopping). 168654
Ware AJ, Luby JP, Eigenbrodt EH, Long DL, Hull AR. Spectrum of liver disease in renal transplant recipients. Gastroenterology 1975; 68: 755-64. (Liver disease developed in 31 of 82 [38%] patients undergoing renal transplantation, 8 with acute self-limited disease, 2 with acute liver failure [1 due to HBV] and 21 with chronic liver injury; all received azathioprine, but no consistent effect of stopping or modifying dose in chronic cases, possibly being due to chronic hepatitis C which could not be serologically identified in 1975). 164401
Marubbio AT, Danielson B. Hepatic veno-occlusive disease in a renal transplant patient receiving azathioprine. Gastroenterology 1975; 69: 739-43. (54 year old man developed jaundice 14 months after renal transplant [bilirubin 5.1 mg/dL, AST 125 U/L, Alk P 1.5 times ULN], progressing to liver failure and death despite stopping azathioprine promptly; biopsies and autopsy showing veno-occlusive disease; patient also had hepatitis B). 1098955
Griner PF, Elbadawi A, Packman CH. Veno-occlusive disease of the liver after chemotherapy of acute leukemia. Report of two cases. Ann Intern Med 1976; 85: 578-82. (Two men with leukemia, ages 17 and 72 years, developed abdominal pain, ascites and progressive liver failure 3-4 months after starting cyclic cytotoxic therapy with multiple agents including thioguanine [initial bilirubin 1.3 and 2.5 mg/dL, AST 348 and 48 U/L, Alk P 92 and 276 U/L]; autopsies showed acute sinusoidal obstruction syndrome [veno-occlusive disease]). 1068643
Minow RA, Stern MH, Casey JH, Rodriguez V, Luna MA. Clinico-pathologic correlation of liver damage in patients treated with 6-mercaptopurine and adriamycin. Cancer 1976; 38: 1524-8. (Combination of adriamycin [50 mg/m2/day] and mercaptopurine [500 mg/m2/day] with vincristine and prednisone for acute leukemia was associated with high rate of hepatotoxicity; in 11 cases, bilirubin rising with each course with mild elevations in ALT and Alk P; liver tissue showing central cholestasis with mild hepatocellular necrosis and fatty change). 1068739
Degott C, Rueff B, Kreis H, DuBoust A, Potet F, Benhamou JP. Peliosis hepatis in recipients of renal transplants. Gut 1978; 19: 748-53. (Among 500 patients undergoing renal transplantation between 1965-75, 55 had liver biopsy, 12 of which showed peliosis hepatis [6 major; 6 minor changes], often in association with chronic hepatitis B; in major forms there was hepatomegaly and portal hypertension; hypothesized possible role of azathioprine). 355072
Nataf C, Feldmann G, Lebrec D, Degott C, Descamps JM, Rueff B, Benhamou JP. Idiopathic portal hypertension(perisinusoidal fibrosis) after renal transplantation. Gut 1979; 20: 531-7. (Two cases of young men developing esophageal varices 1.5 and 7 years after renal transplantation and azathioprine therapy with normal liver tests and liver biopsy, but perisinusoidal fibrosis found on electron microscopy, seemingly improving once azathioprine was stopped). 381128
Topley JM, Benson J, Squier MV, Chessells JM. Hepatotoxicity in the treatment of acute lymphoblastic leukaemia. Med Pediatr Oncol 1979; 7: 393-9. (Among 21 children receiving mercaptopurine for acute leukemia, most had transient ALT elevations, but liver biopsies were often normal or showed minimal changes). 296787
Ware AJ, Luby JP, Hollinger B, Eigenbrodt EH, Cuthbert JA, Atkins CR, Shorey J, et al. Etiology of liver disease in renal-transplant patients. Ann Intern Med 1979; 91: 364-71. (Analysis of 72 episodes of liver disease occurring in 62 of 120 renal transplant recipients; 4 episodes of acute cholestasis were attributed to azathioprine, resolving with stopping or dose reduction; azathioprine did not seem to account for cases of chronic liver injury, responses to stopping being equivocal). 224742
Stromeyer FU, Ishak KG. Nodular transformation(nodular regenerative hyperplasia) of the liver. A clinicopathological study of 30 cases. Hum Pathol 1981; 1: 60-71. (30 cases of nodular regenerative hyperplasia from the files of the Armed Forces Institute of Pathology; ages 14-80 years, half males, 18 discovered incidentally, 84% splenomegaly, 58% ascites, half died, 3 with liver failure, mild elevations in AST and Alk P levels were typical; 6 had rheumatologic disorder, 7 hematologic disease; 10 on corticosteroids, several on azathioprine, but mercaptopurine not specifically mentioned). 7203455
Whisnant JK, Pelkey J. Rheumatoid arthritis: treatment with azathioprine>(IMURAN(R)). Clinical side-effects and laboratory abnormalities. Ann Rheum Dis 1982; 41 Suppl 1: 44-7. (Review of literature on 542 patients in 24 studies given azathioprine for up to 4 years; leucopenia in 26%, gastrointestinal complaints in 19%; only two reports of hepatotoxicity). 7065742
Weitz H, Gokel SM, Loeschke K, Possinger K, Eder M. Venoocclusive disease of the liver in patients receiving immunosuppressive therapy. Virchows Arch [1] 1982; 395: 245-56. PMID: 7051531 (Four cases of sinusoidal obstruction syndrome in 34-41 year old men who developed mild jaundice 9-21 months after renal transplantation [bilirubin 2.8-3.7 mg/dL, ALT 17-60 U/L, Alk P 108-673 U/L], ultimately with fatal outcomes).
D'Cruz CA, Wimmer RS, Harcke HT, Huff DS, Naiman JL. Veno-occlusive disease of the liver in children following chemotherapy for acute myelocytic leukemia. Cancer 1983; 52: 1803-7. (Three children [2 girls and 1 boy, ages 4, 8 and 14] developed sinusoidal obstruction syndrome 5-6 months after starting chemotherapy for leukemia, presenting with abdominal pain and hepatomegaly [bilirubin 1.2-2.0 mg/dL, ALT and Alk P normal], improving on decreasing dose of chemotherapy). 6578867
Harvey C, Dixon JS, Bird HA. Serum IgA concentration and hepatotoxicity in rheumatoid arthritis treated with azathioprine. Br Med J (Clin Res Ed) 1983; 287: 534. (Among 27 patients with rheumatoid arthritis treated with azathioprine [1.5 mg/kg/day], 4 developed ALT elevations 2-8 weeks after starting, all 4 had low levels of IgA before starting [mean=109 mg/dL]). 6411213
DePinho RA, Goldberg CS, Lefkowitch JH. Azathioprine and the liver: evidence favoring idiosyncratic, mixed cholestatic-hepatocellular injury in man. Gastroenterology 1984; 86: 162-5. (22 year old man with lupus erythematosus developed jaundice 3 weeks after starting azathioprine [peak direct bilirubin ~4.9 mg/dL, ALT ~710 U/L, Alk P ~560 U/L], resolving within 6 weeks of stopping; biopsy showed intrahepatic cholestasis with scant inflammation and necrosis: Azathioprine Case 1). 6689657
Eisenhauer T, Hartmann H, Rumpf KW, Helmchen U, Scheler F, Creutzfeldt W. Favorable outcome of hepatic veno-occlusive disease in a renal transplant patient receiving azathioprine, treated by portacaval shunt: report of a case and review of the literature. Digestion 1984; 30: 185-90. (45 year old man developed ascites and abdominal pain 2 years after renal transplant while on azathioprine, biopsy showing veno-occlusive disease and ascites, responding to stopping azathioprine and portacaval shunt). 6389237
Watanabe A, Obata T, Nagashima H, Sakagami K, Orita K. Nonicteric liver damage with a gamma-glutamyl transpeptidase level of 5,609 units/l in a renal-transplant recipient receiving azathioprine. Acta Med Okayama 1984; 38: 533-9.6151783
Pappas SC, Holone DG, Rabin L, Hoofnagle JH, Jones EA. Hepatic veno-occlusive disease in a patient with systemic lupus erythematosus. Arthr Rheum 1984; 27: 104-8. (26 year old woman with lupus erythematosus developed abdominal pain and hepatomegaly [bilirubin 0.5 mg/dL, ALT 21 U/L, Alk P 185 U/L], later developing ascites; biopsies showed sinusoidal obstruction syndrome; only medications had been aspirin and hydroxychloroquine). 6691850
Zimm S, Ettinger LJ, Holcenberg JS, Kamen BA, Vietti TJ, Belasco J, Cogliano-Shutta N, et al. Phase I and clinical pharmacological study of mercaptopurine administered as a prolonged intravenous infusion. Cancer Res 1985; 45: 1869-73. (Among 38 children with acute leukemia treated with cycles of intravenous mercaptopurine, ALT elevations were common, but were transient, asymptomatic and resolved in 5-7 days). 4038917
Gerlag PG, Labatty S, Driessen WM, Deckers PFL, Van Hooff JP, Schroder E, Assmann KM, et al. Hepatic sinusoidal dilatation with portal hypertension during azathioprine treatment after kidney transplantation. J Hepatol 1986; 1: 339-48. (3 patients developed evidence of portal hypertension 16-24 months after renal transplant on azathioprine therapy without portal fibrosis, improvement on stopping, but residual changes found during follow up). 3902952
Read AE, Wiesner RH, La Brecque DR, Tifft JG, Mullen KD, Sheer RL, Petrelle M, et al. Hepatic veno-occlusive disease associated with renal transplantation and azathioprine therapy. Ann Intern Med 1986; 104: 651-6. (Four patients developed sinusoidal obstruction syndrome and signs of portal hypertension 0.5 to 9 years after renal transplantation while on azathioprine; one improved, 3 had progressive problems with portal hypertension and hepatic failure). 3008617
Lemarchand P, Desrumeaux B, Bercoff E, Manchon ND, Chassagne P, Deshayes P, Hémet J, Bourreille J. [Cholestasis and sinusoidal dilatation following treatment with azathioprine]. Gastroenterol Clin Biol 1986; 10: 853-4. French. PMID: 3803830 (53 year old woman with rheumatoid arthritis developed jaundice 6 months after starting azathioprine [bilirubin 12.9 mg/dL, ALT 75 U/L, Alk P 1150 U/L], resolving within 1 month of stopping and relapsing 3 days after rechallenge, biopsy showed sinusoidal dilatation and intrahepatic cholestasis with minimal inflammation).
Kissel JT, Levy RJ, Mendell JR, Griggs RC. Azathioprine toxicity in neuromuscular disease. Neurology 1986; 36: 35-9. (Retrospective review of 64 patients with autoimmune neuromuscular disease treated with azathioprine for 0.5 to 16 years; dose modification for toxicity was done in 42%, most commonly for leucopenia, hepatotoxicity occurred in 9%, arising within 1-8 weeks, resolving within 1-2 months in all; recurrence on rechallenge within days). 3941781
Katzka DA, Saul SH, Jorkasky D, Sigal H, Reynolds JC, Soloway RD. Azathioprine and hepatic venoocclusive disease in renal transplant patients. Gastroenterology 1986; 90: 446-54. (3 men, ages 37-59 years, developed liver test abnormalities [bilirubin 1.5-3.5 mg/dL, ALT 44-86 U/L, Alk P 505-648 U/L] 12-32 months after starting azathioprine, 2 dying and one surviving with improvement after stopping azathioprine; all had nodular regenerative hyperplasia and sinusoidal obstructive changes on biopsy or autopsy). 3510146
Cooper C, Cotton DW, Minihane N, Cawley MI. Azathioprine hypersensitivity manifesting as acute focal hepatocellular necrosis. J R Soc Med 1986; 79: 171-3. (58 year old man with rheumatoid arthritis developed jaundice 2 weeks after starting azathioprine [bilirubin 2.3 mg/dL, ALT >300 U/L, Alk P 898 U/L], liver biopsy showing nonspecific changes and symptoms resolving within 1 week and laboratory abnormalities within 1 month of stopping). 3701755
Barrowman JA, Kutty PK, Mu RA, Huang SN. Sclerosing hepatitis and azathioprine. Dig Dis Sci 1986; 31: 221-2. (35 year old man treated with azathioprine for 8 years developed jaundice [bilirubin 10 mg/dL, AST 350 U/L, Alk P 287 U/L], which progressed to end-stage liver disease and death 5 months later despite stopping azathioprine; clinical course possibly representing vanishing bile duct syndrome). 3943451
Adler M, Delhaye M, Deprez C, Hardy N, Gelin M, DePauw L, Vererstraeten P, et al. Hepatic vascular disease after kidney transplantation: report of two cases and review of the literature. Nephrol Dialysis Transplant 1987; 2: 183-8. (Two men, ages 31 and 40 years, developed portal hypertension due to azathioprine 4 and 8 years after kidney transplant, presenting with fatigue and abdominal distension with mild jaundice and minimal elevations in Alk P and ALT, biopsy showed changes of peliosis and sinusoidal obstruction syndrome; subsequently, both had hepatic decompensation and one died). 3114679
Fonseca V, Havard CW. Portal hypertension secondary to azathioprine in myasthenia gravis. Postgrad med J 1988; 64: 950-2. (52 year old man with myasthenia was found to have splenomegaly 3 years after starting azathioprine [150 mg/day] [bilirubin 4.1 mg/dL, AST 40 U/L, Alk P 107 U/L, platelets 103,000/μL], biopsy showing nodular regenerative hyperplasia with improvement in liver tests [bilirubin 1.2 mg/dL] upon stopping). 3256814
Haboubi MB, Hiam H, Whitwell HL, Ackrill P. Role of endothelial cell injury in the spectrum of azathioprine-induced liver disease after renal transplant: light microscopy and ultrastructural observations. Am J Gastroenterol 1988; 83: 256-61. (3 cases, men, ages 26-44 developing hepatomegaly and signs of portal hypertension 1-5 years after renal transplant while on azathioprine; biopsies showed peliosis and nodular regenerative hyperplasia, 1 died of hepatic failure, 2 improved on stopping azathioprine; suggestive of endothelial cell injury from the thiopurine). 3278593
Buffet C, Cantarovitch M, Pelletier G, Fabre M, Martin E, Charpentier B, Etienne JP, et al. Three cases of nodular regenerative hyperplasia of the liver following renal transplantation. Nephrol Dial Transplant 1988; 3: 327-30. (Three men, ages 22, 29 and 50 years, developed nodular regenerative hyperplasia with hepato-splenomegaly 24-30 months after renal transplant while on azathioprine, two had peliosis and one sinusoidal obstruction syndrome; minimal liver test abnormalities were found in two; jaundice in the third who had a fatal outcome [initial bilirubin 5.8 mg/dL, AST 35 U/L, Alk P 80 U/L]). 3140108
Jones MC, Best PV, Catto GRD. Is nodular regenerative hyperplasia of the liver associated with azathioprine therapy after renal transplantation. Nephrol Dial Transplant 1988; 3: 330-3. (33 year old man developed minor elevations in liver tests starting 15 months after renal transplantation while on azathioprine [bilirubin 1.0 mg/dL, AST 42 U/L, Alk P 185 U/L], later developing hepatomegaly and ascites; biopsy showed nodular regenerative hyperplasia). 3140109
Lemley DE, Delacy LM, Seeff LB, Ishak KG, Nashel DJ. Azathioprine induced hepatic veno-occlusive disease in rheumatoid arthritis. Ann Rheum Dis 1989; 48: 342-6. (59 year old man with rheumatoid arthritis developed abdominal pain 3 months after starting azathioprine with bilirubin 0.2 mg/dL, with minimal elevations in ALT and Alk P; azathioprine was continued and signs of portal hypertension arose 4 months later, biopsy showing sinusoidal obstruction syndrome). 2712618
Small P, Lichter M. Probable azathioprine hepatotoxicity: a case report. Ann Allergy 1989; 62: 518-20. (57 year old woman with rheumatoid arthritis and polymyositis developed AST and Alk P elevations 3 weeks after starting azathioprine, resolving with stopping and recurring with rechallenge, biopsies showed minimal nonspecific changes). 2735558
Ramalho HJ, Terra EG, Cartapatti E, Barberato JB, Alves VA, Gayotto LC, Abbud-Filho M. Hepatotoxicity of azathioprine in renal transplant recipients. Transplant Proc 1989; 21 (1 Pt 2): 1716-7. (2 women and 2 men, ages 28-49 years, developed cholestasis 2-18 months after renal transplant while on azathioprine [bilirubin 9.3-44 mg/dL, ALT 62-842 U/L, Alk P 1-3 times ULN], improving on stopping and reappearing within weeks on restarting azathioprine). 2652562
Adamson PC, Zimm S, Ragab AH, Steinberg SM, Balis F, Kamen BA, Vietti TJ, et al. A phase II trial of continuous-infusion 6-mercaptopurine for childhood solid tumors. Cancer Chemother Pharmacol 1990; 26: 343-4. (Open label trial of cyclic infusions of mercaptopurine in 40 children with leukemia; reversible hepatotoxicity was dose-limiting and occurred in 50% [peak bilirubin 15.8 mg/dL, ALT 1,194 U/L], details not provided). 2208575
Tolman KG. Hepatotoxicity of antirheumatic drugs. J Rheumatol Suppl 1990; 22: 6-11. (Review of hepatotoxicity of drugs used in rheumatology; mentioning acute mixed hepatocellular-cholestatic injury from azathioprine). 2192059
Jeurissen ME, Boerbooms AM, van de Putte LB, Kruijsen MW. Azathioprine induced fever, chills, rash, and hepatotoxicity in rheumatoid arthritis. Ann Rheum Dis 1990; 49: 25-7. (Among 25 patients with rheumatoid arthritis, 3 developed fever and rash within 2 weeks of starting azathioprine; one had cholestasis [bilirubin 1.6 mg/dL, ALT 150 U/L, Alk P 810 U/L], resolving slowly after stopping and fever recurring upon rechallenge). 2138007
Singh G, Fries JF, Williams CA, Zatarain E, Spitz P, Bloch DA. Toxicity profiles of disease modifying antirheumatic drugs in rheumatoid arthritis. J Rheumatol 1991; 18: 188-94. (Analysis of side effects of 7 agents from the ARAMIS database including 2,479 patients [153 on azathioprine, mercaptopurine not mentioned] with rheumatoid arthritis reported 5 instances of liver abnormalities, but no jaundice during ~228 patient years of exposure to azathioprine). 1673721
Horsmans Y, Rahier J, Geubel AP. Reversible cholestasis with bile duct injury following azathioprine therapy. A case report. Liver 1991; 11: 89-93. (67 year old man with polymyositis developed jaundice 3 months after starting azathioprine [bilirubin ~5.0 mg/dL, ALT ~120 U/L, Alk P 550 U/L], liver biopsy showing intrahepatic cholestasis and bile duct injury, resolving within 2 months of stopping). 2051906
Sterneck M, Wiesner R, Ascher N, Roberts J, Ferrell L, Ludwig J, Lake J. Azathioprine hepatotoxicity after liver transplantation. Hepatology 1991; 14: 806-10. (Two patients [58 year old woman and 41 year old man] developed jaundice 2 and 8 weeks after liver transplantation [bilirubin 33.8 and 7.1 mg/dL, AST 456 and 2965 U/L, Alk P not given and 349 U/L], liver biopsies showing centrilobular congestion, sinusoidal dilation and hemorrhagic necrosis suggesting vascular outflow obstruction, both improved on stopping azathioprine, one worsened on rechallenge). 1937385
Mion F, Napoleon B, Berger F, Chevallier M, Bonvoisin S, Descos L. Azathioprine induced liver disease: nodular regenerative hyperplasia of the liver and perivenous fibrosis in a patient treated for multiple sclerosis. Gut 1991; 32: 715-7. (37 year old man with multiple sclerosis developed variceal hemorrhage 7 years after starting azathioprine [100-150 mg/day] with biopsy showing nodular regeneration and perivascular fibrosis without inflammation). 2060883
Gross R, Scapa E. Hepatotoxicity of 6-mercaptopurine in Crohn's disease. Am J Gastroenterol 1992; 87: 1885-6. (27 year old man developed fatigue and jaundice ~3 months after starting mercaptopurine [bilirubin 6.2 mg/dL, ALT 247 U/L, Alk P 120 U/L], improving rapidly on stopping). 1449165
Wagoner LE, Olsen SL, Bristow MR, O'Connell JB, Taylor DO, Lappe DL, Renlund DG. Cyclophosphamide as an alternative to azathioprine in cardiac transplant recipients with suspected azathioprine-induced hepatotoxicity. Transplantation 1993; 56: 1415-8. (29 of 320 cardiac transplant patients developed elevated liver enzymes while on azathioprine which improved when they were switched to cyclophosphamide 30 to 2014 days after transplant [mean bilirubin falling from 4.3 to 1.8 mg/dL, ALT 84 to 44 U/L, Alk P 184 to 149 U/L]; no patient developed rejection and all except one tolerated cyclophosphamide long term). 8279012
Gane E, Portmann B, Saxena R, Wong P, Ramage J, Williams R. Nodular regenerative hyperplasia of the liver graft after liver transplantation. Hepatology. 1994; 20: 88-94. (Nine cases of biopsy proven nodular regenerative hyperplasia in liver transplant recipients arising after 0.5 to 12 years; 6 presenting with ascites or varices and 3 without symptoms [bilirubin 0.5-5.1 mg/dL, AST 36-192 U/L, Alk P 159-1182 U/L], 5 improving on stopping azathioprine and 4 developing progressive hepatic failure; several had earlier biopsies showing venous outflow obstruction). 8020909
Dhillon AP, Burroughs AK, Hudson M, Shah N, Rolles K, Scheuer PJ. Hepatic venular stenosis after orthotopic liver transplantation. Hepatology 1994; 19: 106-11. (Retrospective review of 49 liver biopsies taken after liver transplantation identified 7 patients with venous outflow obstruction usually within 30 days of transplant, associated with endothelitis, only 5 on azathioprine suggesting that changes were due to rejection rather than drug). 8276346
Stetter M, Schmidl M, Krapf R. Azathioprine hypersensitivity mimicking Goodpasture's syndrome. Am J Kidney Dis 1994; 23: 874-7. PubMed Citation (Patient with renal transplant developed fever, arthralgias, diarrhea and pulmonary infiltrates within 7 days of starting azathioprine on three occasions, but later tolerated mercaptopurine suggesting hypersensitivity to nitroimidazole component of azathioprine). 8203372
Gross R. Hepatotoxicity of 6-mercaptopurine and azathioprine. Mayo Clin Proc 1994; 69: 498. (Letter in response to a review article by Stark and Tremaine on use of thiopurines to treat Crohn disease mentioning the problem of hepatotoxicity of mercaptopurine and importance of monitoring for liver test abnormalities). 8170206
Laidlaw ST, Reilly JT, Suvarna SK. Fatal hepatotoxicity associated with 6-mercaptopurine therapy. Postgrad Med J 1995; 71: 639. (68 year old man developed jaundice [bilirubin 9.1 mg/dL, ALT 149 U/L, Alk P 143 U/L] after 5th cycle of chemotherapy for leukemia including mercaptopurine, with progressive hepatic failure and death). 8545299
Kowdley KV, Keeffe EB. Hepatotoxicity of transplant immunosuppressive agents. Gastroenterol Clin North Am 1995; 24: 991-1001. (Review of hepatotoxicity of agents used in solid organ transplantation including azathioprine, [but not specifically mercaptopurine] which causes a broad range of hepatic injuries including transient ALT elevations, cholestasis, sinusoidal dilatation, sinusoidal obstruction syndrome, peliosis and nodular regenerative hyperplasia with portal hypertension). 8749908
Knowles SR, Gupta AK, Shear NH, Sauder D. Azathioprine hypersensitivity-like reactions - a case report and a review of the literature. Clin Exp Dermatol 1995; 20: 353-6. (17 year old girl with vasculitis developed fever and leucopenia 15 days after starting azathioprine with recurrence of fever within 24 hours of restarting; liver tests were normal). 8549000
Romagnuolo J, Sadowski DC, Lalor E, Jewell L, Thomson AB. Cholestatic hepatocellular injury with azathioprine: a case report and review of the mechanisms of hepatotoxicity. Can J Gastroenterol 1998; 12: 479-83. (63 year old man with Crohn disease developed jaundice 9 weeks after starting azathioprine [bilirubin 8.0 mg/dL, AST 65 U/L, Alk P 896 U/L], liver biopsy showed intrahepatic cholestasis, resolved with stopping). 9812167
Griger DR, Higgs JB, Roane DW. Azathioprine hepatotoxicity is uncommon in patients with rheumatic diseases. J Clin Rheumatol 1999; 5: 60-4. (Retrospective review of 56 patients with rheumatic diseases treated with azathioprine, 41% had at least transient elevation in Alk P [146-302 U/L] or AST [39-234 U/L], but levels fell to normal despite continuation in 80% of patients and none were "clinically significant"). 19078358
Mahadevan U, Tremaine WJ, Johnson T, Pike MG, Mays DC, Lipsky JJ, Sandborn WJ. Intravenous azathioprine in severe ulcerative colitis: a pilot study. Am J Gastroenterol 2000; 95: 3463-8. (9 hospitalized patients with refractory ulcerative colitis received 36 hour infusions of azathioprine; 5 had a clinical response and only one had hepatotoxicity [bilirubin not given, ALT 695 U/L, Alk P 474 U/L], resolving within a week of stopping). 11151878
Mok MY, Ng WL, Yuen MF, Wong RW, Lau CS. Safety of disease modifying anti-rheumatic agents in rheumatoid arthritis patients with chronic viral hepatitis. Clin Exp Rheumatol 2000; 18: 363-8. (Retrospective review of 29 Chinese patients with rheumatoid arthritis and chronic hepatitis B [n=23] or C [n=6] receiving disease modifying agents; one patient on azathioprine for 2.7 years developed reactivation of hepatitis B). 10895374
Evans WE, Hon YY, Bomgaars L, Coutre S, Holdsworth M, Janco R, Kalwinsky D, et al. Preponderance of thiopurine S-methyltransferase deficiency and heterozygosity among patients intolerant to mercaptopurine or azathioprine. J Clin Oncol 2001; 19: 2293-301. (Thiopurine S methyltransferase [TPMT] activity was low or deficient in 71% of patients with azathioprine hematologic toxicity, but among 6 patients with hepatoxicity none were deficient, 3 had intermediate and 3 normal levels of TPMT activity). 11304783
Schwab M, Schaeffeler E, Marx C, Fischer C, Lang T, Behrens C, Gregor M, et al. Azathioprine therapy and adverse drug reactions in patients with inflammatory bowel disease: impact of thiopurine S-methyltransferase polymorphism. Pharmacogenetics 2002; 12: 429-36. (Among 93 adults treated with azathioprine, thiopurine S-methyl transferase [TPMT] activities were normal in those with gastrointestinal [n=9] and liver toxicities [n=3], but were low in those with hematological toxicities). 12172211
Sinico RA, Sabadini E, Borlandelli S, Cosci P, Di Toma L, Imbasciati E. Azathioprine hypersensitivity: report of two cases and review of the literature. J Nephrol 2003; 16: 272-6. (Two patients with systemic vasculitis developed fever, rash and malaise 10 and 20 days after starting azathioprine with prompt improvement on stopping and rapid relapse on restarting; no mention of liver test results as being abnormal). 12768076
Rulyak SJ, Saunders MD, Lee SD. Hepatotoxicity associated with 6-thioguanine therapy for Crohn's disease. J Clin Gastroenterol 2003; 36: 234-7. (27 year old with Crohn disease developed asymptomatic rise in ALT to 191 U/L 2 weeks after starting thioguanine, ALT then rising to 803 U/L at 4 weeks with normal Alk P and minimal increase in bilirubin [1.5 mg/dL], resolving within 1 month of stopping). 12590235
Stoneham S, Lennard L, Coen P, Lilleyman J, Saha V. Veno-occlusive disease in patients receiving thiopurines during maintenance therapy for childhood acute lymphoblastic leukaemia. Br J Haematol 2003; 123: 100-2. (Retrospective analysis of sinusoidal obstruction syndrome (SOS) among 99 children who received thioguanine or mercaptopurine for acute leukemia; 12 developed SOS all of whom received thioguanine and were male; no correlation with dose or thiopurine methyltransferase levels). 14510948
Piel B, Vaidya S, Lancaster D, Taj M, Pritchard-Jones K. Chronic hepatotoxicity following 6-thioguanine therapy for childhood acute lymphoblastic leukaemia. Br J Haematol 2004; 125: 410-1; author reply 412. (Letter in response to Stoneham [2003] reporting SOS in 7 of 59 children receiving thioguanine [12%], with chronic liver injury in 7 [suspected to be nodular regenerative hyperplasia]; patients tolerated being switched to mercaptopurine). 15086428
de Abajo FJ, Montero D, Madurga M, Garcia Rodriguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of UK General Practice Research Database found 128 cases of suspected drug induced liver injury [2.4 per 100,000 person-years], 2 anicteric cases were attributed to azathioprine, yielding an odds ratio of 10.5: mercaptopurine not discussed). 15206996
Kontorinis N, Agarwal K, Gondolesi G, Fiel MI, O'Rourke M, Schiano TD. Diagnosis of 6 mercaptopurine hepatotoxicity post liver transplantation utilizing metabolite assays. Am J Transplant 2004; 4: 1539-42. (Two women, ages 46 and 53 years, with liver transplants developed jaundice 5 and 3 months after starting mercaptopurine [bilirubin 11.7 and 8.0 mg/dL, ALT 108 and 392 U/L, Alk P 464 and 395 U/L], resolving within 1-2 months of stopping; neither had TPMT deficiency). 15307844
Nygaard U, Toft N, Schmiegelow K. Methylated metabolites of 6-mercaptopurine are associated with hepatotoxicity. Clin Pharmacol Ther 2004; 75: 274-81. (High frequency of ALT elevations occurred in children with acute leukemia treated with mercaptopurine, usually resolving with stopping or lowering the dose; ALT elevations were associated with higher doses and higher levels of methylated metabolites of mercaptopurine). 15060506
Reuther LO, Vainer B, Sonne J, Larsen NE. Thiopurine methyltransferase(TPMT) genotype distribution in azathioprine-tolerant and -intolerant patients with various disorders. The impact of TPMT genotyping in predicting toxicity. Eur J Clin Pharmacol 2004; 59: 797-801. (Weak correlation found between azathioprine intolerance and TPMT mutations). 14634700
de Boer NK, Mulder CJ, van Bodegraven AA. Myelotoxicity and hepatotoxicity during azathioprine therapy. Neth J Med 2005; 63: 444-6. (38 year old man with Crohn disease was found to have abnormal liver tests and portal hypertension 3 years after starting azathioprine [bilirubin 2.1 mg/dL, ALT 53 U/L, Alk P 141 U/L], improving upon stopping). 16397313
de Boer NK, De Graaf P, Wilhelm AJ, Mulder CJ, van Bodegraven AA. On the limitation of 6-tioguaninenucleotide monitoring during thioguanine treatment. Aliment Pharmacol Ther 2005; 22: 447-51. (Analysis of drug levels in 25 patients switched from azathioprine to thioguanine found no correlation with myelotoxicity; hepatotoxicity not mentioned). 16128683
Bastida G, Nos P, Aguas M, Beltrán B, Rubín A, Dasí F, Ponce J. Incidence, risk factors and clinical course of thiopurine-induced liver injury in patients with inflammatory bowel disease. Aliment Pharmacol Ther 2005; 22: 775-82. (Prospective analysis of 161 patients treated with azathioprine for inflammatory bowel disease; 16 [10%] developed elevations in liver tests at least twice normal after 2 days to 3 years [bilirubin normal, ALT 85-240 U/L, Alk P 48-526 U/L], resolving in all 16 patients including 11 who continued therapy). 16225485
Heckmann JM, Lambson EM, Little F, Owen EP. Thiopurine methyltransferase(TPMT) heterozygosity and enzyme activity as predictive tests for the development of azathioprine-related adverse events. J Neurol Sci 2005; 231: 71-80. (7 of 129 neurological patients on azathioprine developed hepatotoxicity; testing for TPMT activity or mutations had low predictive value). 15792824
Sparrow MP, Hande SA, Friedman S, Lim WC, Reddy SI, Cao D, Hanauer SB. Allopurinol safely and effectively optimizes thioguanine metabolites in inflammatory bowel disease patients not responding to azathioprine and mercaptopurine. Aliment Pharmacol Ther 2005; 22: 441-6. (Adding allopurinol to azathioprine therapy led to higher thioguanine and methyl-mercaptopurine levels, thus allowing for reduction in azathioprine dose, and theoretically better efficacy, lower toxicity). 16128682
Daniel F, Cadranel JF, Seksik P, Cazier A, Duong Van Huyen JP, Ziol M, Coutarel P, et al. Azathioprine induced nodular regenerative hyperplasia in IBD patients. Gastroenterol Clin Biol 2005; 29: 600-34. (Four men, ages 26-46 years, with inflammatory bowel disease developed nodular regenerative hyperplasia 6-12 months after starting azathioprine, presenting with liver test abnormalities and decrease in platelet counts, improving with stopping including slight increase in platelet count: Azathioprine Case 3). 15980758
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Among 446 cases of drug induced liver injury collected in Spain between 1984-2004, azathioprine accounted for 6 cases, ranking 14th; injury usually cholestatic, no fatalities). 16083708
De Bruyne R, Portmann B, Samyn M, Bansal S, Knisely A, Mieli-Vergani G, Dhawan A. Chronic liver disease related to 6-thoguanine in children with acute lymphoblastic leukaemia. J Hepatol 2006; 44: 407-10. (Evaluation of 6 children with acute lymphoblastic leukemia who developed sinusoidal obstructive syndrome during thioguanine therapy; disease progressed despite switching to mercaptopurine biopsies showing nodular regeneration; platelet counts 74-181,000/μL). 16226335
Derijks LJ, Gilissen LP, de Boer NK, Mulder CJ. 6-Thioguanine-related hepatotoxicity in patients with inflammatory bowel disease: dose or level dependent? J Hepatol 2006; 44: 821-2. (Letter in response to De Bruyne [2006] suggesting that use of lower doses and monitoring for metabolites may help avoid hepatotoxicity). 16487623
Seiderer J, Zech CJ, Diebold J, Schoenberg SO, Brand S, Tillack C, Göke B, Ochsenkühn T. Nodular regenerative hyperplasia: a reversible entity associated with azathioprine therapy. Eur J Gastroenterol Hepatol 2006; 18: 553-5. (54 year old developed jaundice 5 months after starting azathioprine for Crohn disease [bilirubin 7.5 mg/dL, but normal serum enzymes]; biopsy showing nodular regenerative hyperplasia, improvement on stopping). 16607155
Heneghan MA, Allan ML, Bornstein JD, Muir AJ, Tendler DA. Utility of thiopurine methyltransferase genotyping and phenotyping, and measurement of azathioprine metabolites in the management of patients with autoimmune hepatitis. J Hepatol 2006; 45: 584-91. (Among 86 patients with autoimmune hepatitis treated with azathioprine, TPMT mutations did not predict toxicities; one patient developed hepatotoxicity with rise in ALT to 3 times ULN that improved with dose reduction). 16876902
Teml A, Schwab M, Hommes DW, Almer S, Lukas M, Feichtenschlager T, Florin T, et al. A systematic survey evaluating 6-thioguanine-related hepatotoxicity in patients with inflammatory bowel disease. Wien Klin Wochenschr 2007; 119: 519-26. (Among 296 patients with inflammatory bowel disease treated with thioguanine for 1 month to 4 years at 15 medical centers, liver enzyme elevations occurred in 43 [15%] and nodular regenerative hyperplasia was found in 16 of 60 patients undergoing liver biopsy; older age was the only risk factor identified). 17943403
Shaye OA, Yadegari M, Abreu MT, Poordad F, Simon K, Martin P, Papadakis KA, et al. Hepatotoxicity of 6-mercaptopurine (6-MP) and azathioprine (AZA) in adult IBD patients. Am J Gastroenterol 2007; 102: 2488-94. (Among 173 adult patients with inflammatory bowel disease treated with azathioprine or mercaptopurine, 8 developed ALT elevations greater than twice ULN [bilirubin 0.3-2.4 mg/dL, ALT 58-434 U/L, Alk P 54-130 U/L], resolving with stopping or lowering dose; toxicity had weak association with higher methyl metabolites in serum). 17764490
Gisbert JP, Luna M, González-Lama Y, Pousa ID, Velasco M, Moreno-Otero R, Maté J. Liver injury in inflammatory bowel disease: long-term follow-up study of 786 patients. Inflamm Bowel Dis 2007; 13: 1106-14. (Long term follow up of 138 patients treated with azathioprine or mercaptopurine; incidence of any abnormal liver test was 7.1% per year, values above twice ULN occurred in only 2.6% and often resolved spontaneously; 5 of 49 required discontinuation). 17455203
Gisbert JP, González-Lama Y, Maté J. Thiopurine-induced liver injury in patients with inflammatory bowel disease: a systematic review. Am J Gastroenterol 2007; 102: 1518-27. (Systematic review of the literature on hepatotoxicity of thiopurines in patients with inflammatory bowel disease; rates of hepatotoxicity have ranged from 0% to 13% [averaging 1.4% per year], depending upon definition of injury and degree of monitoring; these agents can also cause syndromes of acute hypersensitivity reactions, acute cholestasis and chronic injury of endothelial cell injury and nodular regenerative hyperplasia). 17391318
Gilissen LP, Derijks LJ, Driessen A, Bos LP, Hooymans PM, Stockbrügger RW, Engels LG. Toxicity of 6-thioguanine: no hepatotoxicity in a series of IBD patients treated with long-term, low dose 6-thioguanine. Some evidence for dose or metabolite level dependent effects? Dig Liver Dis 2007; 39: 156-9. (Among 13 patients with inflammatory bowel disease treated with thioguanine for at least 2 years, none had evidence of nodular regeneration by either liver biopsy [n=11] or imaging studies [n=11]). 17188950
de Boer NK, van Bodegraven AA, Jharap B, de Graaf P, Mulder CJ. Drug Insight: pharmacology and toxicity of thiopurine therapy in patients with IBD. Nat Clin Pract Gastroenterol Hepatol 2007; 4: 686-94. (Review of pharmacokinetics and metabolism of thiopurines and management of intolerance using genetic tests for TPMT and measurements of metabolites). 18043678
Contreras AM, Monteón FJ, Flores MR, Mendoza-Sánchez F, Ruiz I. Drug-related hepatotoxicity in a renal transplant recipient with long-term survival and hepatitis C. Ann Hepatol 2007; 6: 70-3. (53 year old man with renal transplant developed ALT elevations during long term azathioprine therapy, but was subsequently found to have acquired chronic hepatitis C as a possible reason for the liver injury). 17297434
Gardiner SJ, Gearry RB, Burt MJ, Ding SL, Barclay ML. Severe hepatotoxicity with high 6-methylmercaptopurine nucleotide concentrations after thiopurine dose escalation due to low 6-thioguanine nucleotides. Eur J Gastroenterol Hepatol 2008; 20: 1238-42. (3 patients with autoimmune disorders developed hepatotoxicity 1-4 months after the dose of mercaptopurine or azathioprine was increased [bilirubin 6.9, 37 and 21.2 mg/dL, ALT 195, 200 and 79 U/L, Alk P 123, 109 and 194 U/L]; two progressed to hepatic failure and died; methyl-metabolites of mercaptopurine were elevated in all 3). 18989148
Leong RW, Gearry RB, Sparrow MP. Thiopurine hepatotoxicity in inflammatory bowel disease: the role for adding allopurinol. Expert Opin Drug Saf 2008; 7: 607-16. (Allopurinol can increase levels of mercaptopurine and allow for dose reductions as well as shift its metabolism towards the active [6-thioguanine nucleotides] and away from toxic metabolites [methyl-mercaptopurine ribonucleotide], but requires monitoring). 18759713
Lees CW, Maan AK, Hansoti B, Satsangi J, Arnott DR. Tolerability and safety of mercaptopurine in azathioprine-intolerant patients with inflammatory bowel disease. Aliment Pharmacol Ther 2008; 27: 220-7. (Retrospective analysis of 61 patients with inflammatory bowel disease who were intolerant to azathioprine; 36 [59%] were able to tolerate mercaptopurine, including 3 of 9 with hepatotoxicity). 17988235
Ehmsen L, Marko C, Breidert M. [Portal vein hypertension during azathioprine therapy in patients with Crohn's disease - a frequent phenomenon?]. Dtsch Med Wochenschr 2008; 133: 950-3. German. PMID: 18431703 (45 year old man with Crohn disease on azathioprine for 4 years developed variceal hemorrhage [bilirubin 4.1 mg/dL, normal ALT, platelets 84,000/.L] and was found to have nodular regenerative hyperplasia on liver biopsy, and subsequently improved on stopping azathioprine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 were attributed to mercaptopurine, but none to azathioprine or thioguanine). 18955056
Rahhal RM, Bishop WP. Initial clinical experience with allopurinol-thiopurine combination therapy in pediatric inflammatory bowel disease. Inflamm Bowel Dis 2008; 14: 1678-82. (Description of 13 children with inflammatory bowel disease who were treated with allopurinol and had dose reduction of azathioprine [by ~60%] with overall increase in serum 6-thioguanine levels and decrease in methyl-metabolites; ALT elevations improved in all). 18521913
Ansari A, Elliott T, Baburajan B, Mayhead P, O'Donohue J, Chocair P, Sanderson J, et al. Long-term outcome of using allopurinol co-therapy as a strategy for overcoming thiopurine hepatotoxicity in treating inflammatory bowel disease. Aliment Pharmacol Ther 2008; 28: 734-41. (11 patients with inflammatory bowel disease who developed hepatotoxicity within 1-8 weeks of starting azathioprine [n=10] or mercaptopurine [n=1] were treated with allopurinol and low doses of the thiopurine; 9 tolerated long term therapy without recurrence). 19145729
Xin HW, Xiong H, Wu XC, Li Q, Xiong L, Yu AR. Relationships between thiopurine S-methyltransferase polymorphism and azathioprine-related adverse drug reactions in Chinese renal transplant recipients. Eur J Clin Pharmacol 2009; 65: 249-55. (Association found between TPMP activity and hemato- but not hepato-toxicity; only 2 of 16 patients with hepatotoxicity were heterozygous for TPMT mutations, none were homozygous). 19048245
Hindorf U, Johansson M, Eriksson A, Kvifors E, Almer SH. Mercaptopurine treatment should be considered in azathioprine intolerant patients with inflammatory bowel disease. Aliment Pharmacol Ther 2009; 29: 654-61. (Analysis of usefulness of measuring thiopurine metabolites in management of 238 patients with autoimmune hepatitis on azathioprine, finding it useful only in managing patients with a poor response; patients with hepatotoxicity were not able to tolerate switch to mercaptopurine). 19183142
Murakami A, Tanaka Y, Ueda M, Nagano Y, Kunisaki R, Morimoto M, Enaka M, et al. Hepatocellular carcinoma occurring in a young Crohn's disease patient. Pathol Int 2009; 59: 492-6. (25 year old man with 12 year history of Crohn disease presented with hepatocellular carcinoma approximately one year after starting infliximab; no other risk factors identified; review of literature identified 7 cases of liver cancer in patients with Crohn disease, mean age 20 years, all had received azathioprine and two infliximab). 19563414
Moran G, Dillon J, Green J. Crohn's disease, hepatosplenic T-cell lymphoma and no biological therapy: are we barking up the wrong tree? Inflamm Bowel Dis 2009; 15 (9): 1281-2. (Although fewer than 200 cases of hepatosplenic T cell lymphoma [HSTCL] have been described in the literature, 23 have occurred in patients with inflammatory bowel disease, all of whom were on thiopurines and 16 also on anti-tumor necrosis factor antagonists [anti-TNF]; the authors describe a 23 year old man with ulcerative colitis treated with azathioprine for 7 years without anti-TNF who developed HSTCL). 19067412
Beigel F, Jürgens M, Tillack C, Subklewe M, Mayr D, Göke B, Brand S, et al. Hepatosplenic T-cell lymphoma in a patient with Crohn's disease. Nat Rev Gastroenterol Hepatol 2009; 6: 433-6. (58 year old man with 35 year history of Crohn disease on azathioprine for 5 years developed HSTCL). 19575026
Murakami A, Tanaka Y, Ueda M, Nagano Y, Kunisaki R, Morimoto M, Enaka M, et al. Hepatocellular carcinoma occurring in a young Crohn's disease patient. Pathol Int 2009; 59: 492-6. (25 year old Japanese man with 12 year history of Crohn disease on azathioprine and infliximab presented with abdominal pain and 8 cm HCC without cirrhosis in the non-tumorous liver). 19563414
Miura H, Kawaguchi T, Takazoe M, Kitamura S, Yamada H. Hepatocellular carcinoma and Crohn's disease: a case report and review. Intern Med 2009; 48: 815-9. (52 year old Japanese man with 36 year history of Crohn disease, but never treated with thiopurines presented with hepatic mass, found to be HCC with chronic hepatitis in non-tumorous liver tissue). 19443977
Ishida M, Naka S, Shiomi H, Tsujikawa T, Andoh A, Nakahara T, Saito Y, et al. Hepatocellular carcinoma occurring in a Crohn's disease patient. World J Gastroenterol 2010; 16: 3215-8. (37 year old Japanese man with 7 year history of Crohn disease developed 3 to 4 cm HCC, with focal hepatic glycogenosis without cirrhosis in the non-tumorous liver and with successful resection). 20593510
Ochenrider MG, Patterson DJ, Aboulafia DM. Hepatosplenic T-cell lymphoma in a young man with Crohn's disease: case report and literature review. Clin Lymphoma Myeloma Leuk 2010; 10: 144-8. (18 year old man with 5 year history of Crohn disease treated with mercaptopurine developed HSTCL [bilirubin and ALT levels normal]). 20371449
Thai A, Prindiville T. Hepatosplenic T-cell lymphoma and inflammatory bowel disease. J Crohns Colitis 2010; 4: 511-22. (Review of the association of HSTCL and inflammatory bowel disease). 21122554
Bermejo F, López-Sanromán A, Algaba A, Van-Domselaar M, Gisbert JP, García-Garzón S, Garrido E, et al. Mercaptopurine rescue after azathioprine-induced liver injury in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 120-4. (Retrospective analysis of 31 patients with inflammatory bowel disease who were switched from azathioprine to mercaptopurine because of liver toxicity; in 87% mercaptopurine was tolerated without evidence of further toxicity). 19709096
Leung Y, Sparrow MP, Schwartz M, Hanauer SB. Long term efficacy and safety of allopurinol and azathioprine or 6-mercaptopurine in patients with inflammatory bowel disease. J Crohns Colitis 2009; 3: 162-7. (Among 25 patients with inflammatory bowel disease switched from thiopurines to thioguanine and allopurinol for up to two years, none developed abnormal liver tests or thrombocytopenia). 21172265
Takatsu N, Matsui T, Murakami Y, Ishihara H, Hisabe T, Nagahama T, Maki S, et al. Adverse reactions to azathioprine cannot be predicted by thiopurine S-methyltransferase genotype in Japanese patients with inflammatory bowel disease. J Gastroenterol Hepatol 2009; 24: 1258-64. (TPMT deficiency variants were rare [~2%] in Japanese subjects and were not increased among those with azathioprine intolerance due to toxicity; 2 cases had hepatotoxicity). 19682195
Germani G, Pleguezuelo M, Villamil F, Vaghjiani S, Tsochatzis E, Andreana L, Burroughs AK. Azathioprine in liver transplantation: a reevaluation of its use and a comparison with mycophenolate mofetil. Am J Transplant. 2009; 9: 1725-31. (Review of literature suggests that there is no evidence for added benefit of mycophenolate over azathioprine for prevention of rejection or graft survival after liver transplantation; no discussion of hepatotoxicity). 19538488
Hunt CM. Mitochondrial and immunoallergic injury increase risk of positive drug rechallenge after drug-induced liver injury: a systematic review. Hepatology 2010; 52: 2216-22. (Systematic review of literature on drug rechallenge after acute injury; positive rechallenge after azathioprine hepatotoxicity is common and can be severe). 21105110
Andrejic J, Rojas-Balcazar J, Dennis M, Berkelhammer C. Azathioprine-induced hypersensitivity hepatitis: tolerance to 6-mercaptopurine. Inflamm Bowel Dis. 2010; 16: 1828-9. (50 year old man with ulcerative colitis developed jaundice 4 weeks after starting azathioprine [bilirubin 4.6 mg/dL, ALT 1077 U/L, Alk P 361 U/L], resolving upon stopping and not recurring when treated with mercaptopurine [for up to 6 years]). 20196148
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to azathioprine or mercaptopurine). 20949552
Ishida M, Naka S, Shiomi H, Tsujikawa T, Andoh A, Nakahara T, Saito Y, et al. Hepatocellular carcinoma occurring in a Crohn's disease patient. World J Gastroenterol 2010; 16: 3215-8. (37 year old Japanese man with Crohn disease treated with azathioprine for 8 years developed liver cancer without cirrhosis, but with glycogenosis present; review of 10 reported cases, all without cirrhosis). 20593510
Bryant DL, Miles CJ, Gearry RB. Nodular regenerative hyperplasia of the liver secondary to azathioprine in a patient with inflammatory bowel disease. N Z Med J 2010; 123: 74-6. (54 year old man developed ascites and splenomegaly 18 months after starting azathioprine for Crohn's disease, biopsy showing nodular regenerative hyperplasia, improving upon stopping). 20581898
Okan G, Vural P, Peker O, Colakoglu E, Saruc M. Azathioprine-induced liver injury in a patient with multiple autoimmune syndrome. J Dermatolog Treat 2010; 21: 357-60. (39 year old man with autoimmune disease developed abnormal liver tests 3 weeks after starting azathioprine [bilirubin normal, GGT 2768 U/L, Alk P 306 U/L], resolving within 2 months of stopping). 20443662
López-Martín C, de la Fuente-Fernández E, Corbatón P, Sánchez MC, Gisbert JP. [Nodular regenerative hyperplasia: azathioprine-induced hepatotoxicity in a patient with Crohn's disease]. Gastroenterol Hepatol 2011; 34: 16-9. Spanish. PMID: 21168244 (53 year old man developed abnormal liver tests after 5 years of azathioprine therapy [7 months after dose increase] for Crohn disease [bilirubin 2.2 mg/dL, ALT 61 U/L, Alk P 284 U/L], with esophageal varices and biopsy showing nodular regenerative hyperplasia; slow improvement upon stopping).
Blogowski W, Marlicz W, Smereczynski A, Lawniczak M, Lewosiuk A, Starzynska T. Nodular regenerative liver hyperplasia as a complication of azathioprine-containing immunosuppressive treatment for Crohn's disease. Immunopharmacol Immunotoxicol 2011; 33: 398-402. (40 year old woman with Crohn disease developed nodular regenerative hyperplasia [splenomegaly and varices] 3 years after starting azathioprine). 20726808
van Asseldonk DP, Jharap B, Kuik DJ, de Boer NK, Westerveld BD, Russel MG, Kubben FJ, et al. Prolonged thioguanine therapy is well tolerated and safe in the treatment of ulcerative colitis. Dig Liver Dis 2011; 43: 110-5. (Among 46 patients switched from other thiopurines to thioguanine and treated for an average of two years, none developed hepatotoxicity and liver biopsies done in 12 showed no evidence of nodular regeneration). 20739231
Seksik P, Mary JY, Beaugerie L, Lémann M, Colombel JF, Vernier-Massouille G, Cosnes J. Incidence of nodular regenerative hyperplasia in inflammatory bowel disease patients treated with azathioprine. Inflamm Bowel Dis 2011; 17: 565-72. (Among 1888 patients with inflammatory bowel disease treated with azathioprine for median of 2.5 years, 15 developed nodular regenerative hyperplasia, 0.6% at 5 and 1.3% at 10 years; predictive factors were male gender and history of small bowel resection). 20848502
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of the hepatotoxicity of antirheumatic drugs including azathioprine; acute cholestatic injury occurs in 1:1000 treated subjects, mechanism may be immunologic, metabolic, and/or genetic). 21263458
Adam de Beaumais T, Fakhoury M, Medard Y, Azougagh S, Zhang D, Yakouben K, Jacqz-Aigrain E. Determinants of mercaptopurine toxicity in paediatric acute lymphoblastic leukemia maintenance therapy. Br J Clin Pharmacol 2011;71: 575-84. (66 children with acute leukemia treated with mercaptopurine were tested for thiopurine methyltransferase [TPMT] and inosine pyrophosphatase (ITPA) polymorphisms and for serum levels of mercaptopurine and metabolites; those with higher levels of methyl metabolites [which varied by ITPA genotype] were more likely to have hepatotoxicity, present in 84% of participants). 21395650
Calabrese E, Hanauer SB. Assessment of non-cirrhotic portal hypertension associated with thiopurine therapy in inflammatory bowel disease. J Crohns Colitis 2011; 5: 48-53. (Review of thiopurine toxicity and its management, highlighting a case of nodular regenerative hyperplasia in a patient with Crohn colitis treated with mercaptopurine). 21272804
Tuyama AC, Krakauer M, Alzaabi M, Fiel MI, Legnani P, Schiano TD. Mercaptopurine-induced hepatoportal sclerosis in a patient with Crohn's disease. J Crohns Colitis 2013; 7 (7): 590-3. (23 year old man with Crohn disease treated with mercaptopurine for 6 years developed thrombocytopenia, splenomegaly and abnormal liver tests [bilirubin 0.5 mg/dL, ALT 62 U/L, Alk P 164 U/L, platelets 141,000/μL], with ascites and esophageal varices, liver biopsy showing "hepatoportal sclerosis" without cirrhosis). 22841133
Masia R, Pratt DS, Misdraji J. A histopathologic pattern of centrilobular hepatocyte injury suggests 6-mercaptopurine-induced hepatotoxicity in patients with inflammatory bowel disease. Arch Pathol Lab Med 2012; 136: 618-22. (Histological review of 3 cases of mercaptopurine hepatotoxicity [aminotransferase elevations only] showed minimal lobular inflammation and fibrosis, and prominent centrilobular injury, steatosis and ceroid laden macrophages). 22646267
Laish I, Pomeranz I, Kitay-Cohen Y, Konikof F. [Thiopurine-induced hyperammonaemic encephalopathy in a patient with Crohn's disease]. Harefuah 2012; 151: 692-5, 720. Hebrew. PMID: 23330262 (Patient with Crohn disease developed noncirrhotic portal hypertension complicated by hyperammonemic coma during mercaptopurine therapy).
Cohen-Ezra O, Avni Y, Morgenstern S, Ben-Ari Z. [Nodular regenerative hyperplasia as a complication of thiopurine treatment in a patient with inflammatory bowel disease]. Harefuah 2012; 151: 675-8, 721. Hebrew. PMID: 23330258 (40 year old man developed thrombocytopenia and liver enzyme elevations during therapy with thiopurine, later developing variceal hemorrhage despite stopping therapy).
Choudhary NS, Gupta S, Chawla YK, Duseja A, Dhiman RK, Das A. Azathioprine induced liver injury: a case report. Dig Dis Sci 2012; 57: 1717-8. (61 year old man developed jaundice 16 days after starting azathioprine [bilirubin 9.2 rising to 21.6 mg/dL, ALT 138 U/L, Alk P 3 times ULN], resolving within 6 months of stopping). 22526581
van Asseldonk DP, Seinen ML, de Boer NK, van Bodegraven AA, Mulder CJ. Hepatotoxicity associated with 6-methyl mercaptopurine formation during azathioprine and 6-mercaptopurine therapy does not occur on the short-term during 6-thioguanine therapy in IBD treatment. J Crohns Colitis 2012; 6: 95-101. (Among 19 patients with inflammatory bowel disease who developed serum enzyme elevations during azathioprine or mercaptopurine therapy, none developed liver injury during thioguanine therapy and mean ALT values decreased [64 to 20 U/L]). 22261533
Hoentjen F, Seinen ML, Hanauer SB, de Boer NK, Rubin DT, Bouma G, Harrell LE, van Bodegraven AA. Safety and effectiveness of long-term allopurinol-thiopurine maintenance treatment in inflammatory bowel disease. Inflamm Bowel Dis 2013; 19: 363-9. (Among 36 patients with inflammatory bowel disease who developed ALT elevations during thiopurine therapy and were treated with low doses of thiopurines and allopurinol, ALT levels became normal in 24 and mean values decreased from 38 [range 21-84] to 21 [range 15-26] U/L). 22605661
Selvaraj SA, Chairez E, Wilson LM, Lazarev M, Bass EB, Hutfless S. Use of case reports and the Adverse Event Reporting System in systematic reviews: overcoming barriers to assess the link between Crohn's disease medications and hepatosplenic T-cell lymphoma. Syst Rev 2013; 2: 53. (Review of the literature and spontaneous reports made to the FDA of HSTCL and medication use, identified 37 cases, ages 12 to 79 [mean 30] years; 86% male; disease duration 4 to 35 [mean 10] years; 96% having received thiopurines, 76% biologics; survival poor [8%]). 23826928
Bašić Kinda S, Duraković N, Dotlić S, Serventi Seiwerth R, Davidović Mrsić S, Dubravčić K, Aurer I. Hepatosplenic αβ T-cell lymphoma arising after long-term azathioprine therapy successfully treated with allogeneic bone marrow transplant. Leuk Lymphoma 2013; 54: 1334-5. (Report of a patient with Crohn disease who developed HSTCL after 7 years of azathioprine therapy, few details provided). 23083012
Björnsson ES. Epidemiology and risk factors for idiosyncratic drug-induced liver injury. Semin Liver Dis 2014; 34: 115-22. (Review of the epidemiology of drug induced liver injury mentions that the estimated crude risk of hepatotoxicity from azathioprine is 1 per 1,103 exposed patients). 24879977
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to azathioprine or mercaptopurine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 10 [1.3%] cases were attributed to azathioprine and 9 [1.2%] to mercaptopurine, thus representing the 13th and 14th most frequent prescription drugs implicated). 25754159
Botros Y, Mathews M, Patel H, Shah N, Baddoura W, de la Torre A. Recurrent hepatocellular carcinoma in patient with Crohn's disease: incidental or expected outcome of azathioprine? Case Rep Gastrointest Med 2015; 2015: 939136. (62 year old man with Crohn disease and azathioprine therapy for 21 years, developed HCC with recurrence after resection; no mention of cirrhosis). 26788381
Brinkert F, Arrenberg P, Krech T, Grabhorn E, Lohse A, Schramm C. Two cases of hepatosplenic T-cell lymphoma in adolescents treated for autoimmune hepatitis. Pediatrics 2016; 138. pii: e20154245. (Two patients who developed HSTCL during azathioprine therapy of autoimmune hepatitis: 21 year old man treated for 5 years and an 18 year old female treated for 4 years, both presenting with hepatosplenomegaly, fever and pancytopenia). 27516526
Suárez Ferrer C, Llop Herrera E, Calvo Moya M, Vera Mendoza MI, González Partida I, González Lama Y, Matallana Royo V, et al. Idiopathic portal hypertension regarding thiopurine treatment in patients with inflammatory bowel disease. Rev Esp Enferm Dig 2016; 108: 79-83. (Among 1419 patients with inflammatory bowel disease followed at a referral center in Spain, 927 were treated with thiopurines, of whom 63 [7%] developed liver injury, mostly hepatotoxicity that resolved with dose modification or discontinuation, but 4 had portal hypertension and probable nodular regenerative hyperplasia [ages 42-72 years, treated for 2.5-10 years, bilirubin 0.4-2.2 mg/dL, ALT 21-65 U/L, platelet counts 60,000-100,000]). 26838489
van de Meeberg MM, Derikx LA, Sinnige HA, Nooijen P, Schipper DL, Nissen LH. Hepatosplenic T-cell lymphoma in a 47-year-old Crohn's disease patient on thiopurine monotherapy. World J Gastroenterol 2016; 22: 10465-10470. (47 year old man with Crohn disease on azathioprine therapy developed hepatosplenic T-cell lymphoma, few details provided). 28058028
Heron V, Fortinsky KJ, Spiegle G, Hilzenrat N, Szilagyi A. Resected hepatocellular carcinoma in a patient with Crohn's disease on azathioprine. Case Rep Gastroenterol 2016; 10: 50-6. (61 year old woman with 30 year history of Crohn disease and 10 years of azathioprine therapy presented with liver mass with HCC on biopsy without cirrhosis, but no malignancy at time of resection several months later). 27403102
Björnsson ES, Gu J, Kleiner DE, Chalasani N, Hayashi PH, Hoofnagle JH; DILIN Investigators. Azathioprine and 6-mercaptopurine-induced liver injury: clinical features and outcomes. J Clin Gastroenterol 2017; 51: 63-9. (Among 10 cases of mercaptopurine induced liver injury enrolled in a prospective US database, 9 patients were adults being treated for autoimmune conditions and one a child with leukemia; latency ranged from 2 months to several years, but usually was within 3 months of starting therapy or a major dose escalation, the disease being anicteric in 2, icteric in 8, severe in 5, with initial bilirubin 0.7-21.9 [mean=10 .6] mg/dL, ALT 64-539 [mean=121] U/L, Alk P 35-187 [mean=143] U/L and liver biopsy showing cholestatic hepatitis and mild-to-moderate bile duct injury but no duct loss; cases due to azathioprine [n=12] tended to be similar in clinical characteristics, although somewhat less severe in course and outcome). 27648552
Ebbesen MS, Nygaard U, Rosthøj S, Sørensen D, Nersting J, Vettenranta K, Wesenberg F, et al. Hepatotoxicity during maintenance therapy and prognosis in children with acute lymphoblastic leukemia. J Pediatr Hematol Oncol. 2017;39:161-166.. (Among 385 children [ages 1-15 years] with ALL enrolled in a long-term prospective study of mercaptopurine and methotrexate therapy, ALT levels rose above the upper limit of normal in 91%, elevations correlated with mercaptopurine dose and not with response or relapse, highest levels correlating with thiopurine methyltransferase activity). 28060115
Siramolpiwat S, Sakonlaya D. Clinical and histologic features of azathioprine-induced hepatotoxicity. Scand J Gastroenterol. 2017;52:876-880.. (Among 293 patients treated with azathioprine at a single medical center in Thailand between 2010 and 2015, 8 [2.7%] developed evidence of hepatotoxicity with a mean latency of 86 days [range 7 to 236], with peak median ALT 295 U/L, Alk P 167 U/L, bilirubin 1.0 mg/dL; 4 with symptoms, 3 with jaundice [bilirubin 8.3, 11.9 and 13.4 mg/dL], one rechallenged with recurrence, no deaths, all recovering without transplantation). 28388864
Koller T, Galambosova M, Filakovska S, Kubincova M, Hlavaty T, Toth J, Krajcovicova A, et al. Drug-induced liver injury in inflammatory bowel disease: 1-year prospective observational study. World J Gastroenterol. 2017;23:4102-4111. (Among 251 patients with inflammatory bowel disease followed at a single referral center in Slovakia while monitoring for liver tests at 3 month intervals, ALT elevations above twice ULN arose in 3% but none above 5 times ULN and all were transient or due to other liver conditions while the combination of Alk P and GGT elevations arose in 1% but a higher proportion of those on azathioprine alone [3%] but none were associated with jaundice and only one required dose modification). 28652663
Wang CH, Chi MH, Lin JY, Chung WH, Chen CB. NUDT15 polymorphism identified in a patient with azathioprine hypersensitivity syndrome presenting as erythema nodosum and hepatotoxicity. Br J Dermatol. 2019;181:631-632.. (A 37 year old Chinese woman with idiopathic urticaria developed pruritus, fever, and rash two weeks after starting azathioprine [bilirubin 2.3 mg/dL, ALT 184 U/L, Alk P 184 U/L], skin biopsy demonstrating erythema nodosum and genetic analyses showing mutation in NUDT15, which is associated with excessive levels of thiopurine metabolites, especially in Asians). 30843183
Gisi K, Ispiroglu M, Kantarceken B, Sayar H. Severe cholestasis due to azathioprine in Behcet's disease. BMJ Case Rep. 2019;12:e226340. (33 year old Turkish man with Behcet disease developed pruritus and jaundice 1.5 months after starting azathioprine [bilirubin 18 mg/dL, ALT 57 U/L, Alk P 95 U/L, GGT 39 U/L, INR 1.6]; improvement started soon after stopping and all tests were normal 2 months later). 30936327
Nasser R, Kurnik D, Lurie Y, Nassar L, Yaacob A, Veitsman E, Waterman M, et al. Thiopurine hepatotoxicity can mimic intrahepatic cholestasis of pregnancy. Clin Res Hepatol Gastroenterol. 2020;44:e29-e31.. (31 year old Israeli woman with Crohn disease on long-term azathioprine continued therapy [75 mg daily] during a first pregnancy without difficulty but then required a dose increase to 125 mg daily and developed pruritus, rash, and abnormal liver tests during the 23rd week of a second pregnancy with persistence of symptoms and liver abnormalities (bilirubin 2.4 mg/dL, bile acids markedly elevated] despite ursodiol therapy but with prompt improvement on stopping azathioprine). 31109900
Kreijne JE, de Veer RC, de Boer NK, Dijkstra G, West R, Moorsel SAW, de Jong DJ, et al.; of the Dutch Initiative on Crohn, Colitis (ICC). Real-life study of safety of thiopurine-allopurinol combination therapy in inflammatory bowel disease: myelotoxicity and hepatotoxicity rarely affect maintenance treatment. Aliment Pharmacol Ther. 2019;50:407-415.. (Among 221 patients with inflammatory bowel disease treated with “low-dose thiopurine with allopurinol” in six medical centers in the Netherlands between 2009 and 2016, 34 patients initiated this approach because of hepatotoxicity, and it resolved in 29). 31359480
Stuckert AJ, Schafer ES, Bernhardt MB, Baxter P, Brackett J. Use of allopurinol to reduce hepatotoxicity from 6-mercaptopurine (6-MP) in patients with acute lymphoblastic leukemia (ALL). Leuk Lymphoma. 2020;61:1246-1249.. (Among 19 patients with mercaptopurine toxicity who underwent dose reduction and addition of allopurinol [to skew metabolism from toxic and towards active intermediates], the majority had improvements in serum ALT levels). 31842647
Phillips J, Preskey R, Penfold C, Gordon F, Tyrrell-Price J. Liver steatosis is a risk factor for hepatotoxicity in inflammatory bowel disease patients treated with azathioprine. Eur J Gastroenterol Hepatol. 2020;32:1390-1394.. (Among 91 patients with inflammatory bowel disease treated with azathioprine, ALT levels increased more in those with steatosis by ultrasound before treatment [mean levels rising from 31 to 39 U/L than those without steatosis [mean levels decreasing from 19 to 18 U/L). 32091439
Cablay K, Borowicz VM, Fulton R. Suspected drug-induced liver injury due to 6-mercaptopurine with a superimposed SARS-Cov-2 infection in a patient with B-ALL. J Pediatr Hematol Oncol. 2022;44:e792-e794.. (16 year old male with B-cell ALL was found to have abnormal liver tests at the time of the 4th cycle of chemotherapy with vincristine, methotrexate, prednisone, and mercaptopurine [bilirubin 3.8 rising to 6.3 mg/dL, ALT 81 rising to 130 U/L, Alk P normal, INR 1.6] found then to have concurrent SAR-Co-2 infection, liver tests rapidly improving with pausing chemotherapy, and not worsening with its re-introduction). 35091518
Cataletti G, Santagata F, Pastorelli L, Battezzati PM. Severe azathioprine-induced liver injury 22 months after initiation of treatment. BMJ Case Rep. 2022;15:e253505. (50 year old woman with myasthenia gravis developed abdominal pain and jaundice 22 months after starting azathioprine at 300 mg daily [bilirubin 11.6 rising to 35.6 mg/dL, peak ALT 50 U/L, Alk P peak 222 U/L], with accompanying pancytopenia [platelets 27,000/μL, white count 1760/μL,Hgb 7.7 g/dL] and acute renal failure [creatinine 3.9 mg/dL] resolving completely with stopping and with normal tests 3 months later). 36543371
Chouchana L, Terris B, Sogni P, Treluyer JM, Costedoat-Chalumeau N, Loriot MA. Azathioprine-induced vanishing bile duct syndrome: The value of early thiopurine metabolism assessment. Br J Clin Pharmacol. 2023 Aug;89(8):2625-2630. doi: . Epub 2023 Jun 6..10.1111/bcp.15797 (34 year old woman with lupus erythematosus developed fluctuating aminotransferase elevations [ALT 150 and 115 U/L] 3 months after starting azathioprine [150 mg daily] and at 6 months developed jaundice and fatigue [bilirubin 4.9 mg/dL, ALT 46 U/L, Alk P 121 U/L] with high levels of methylmercaptopurine nucleotides [MMPN], low levels of 6-thioguanine nucleotides [6-TGN] and high thiopurine methyltransferase activity [TPMT]; liver test abnormalities persisted despite stopping therapy and liver biopsy showed bile duct paucity, whereafter liver tests slowly improved with time). 37218386
Frank Wolf M, Sloma R, Akria L, Rimon E, Wiener Y, Carmiel Haggai M, Lowenstein L. Azathioprine and 6-mercaptopurine-induced intrahepatic cholestasis of pregnancy: Case report and review of the literature. Taiwan J Obstet Gynecol. 2023;62:761-764.. (35 year old woman with Crohn disease and history of idiopathic cholestasis of pregnancy [ICP] on long-term mercaptopurine [50 mg/day] developed pruritus after 29 weeks of a 2nd pregnancy that worsened despite therapy with ursodiol, cholestyramine, and rifampin but improved rapidly with stopping mercaptopurine; identifies 11 cases of similar worsening of ICP with thiopurines ). 37679010
Makuuchi M, Kakuta Y, Umeno J, Fujii T, Takagawa T, Ibuka T, Miura M, et al.; Post-MENDEL study group; Kinouchi Y, Andoh A, Hisamatsu T, Masamune A. Real-world NUDT15 genotyping and thiopurine treatment optimization in inflammatory bowel disease: a multicenter study. J Gastroenterol. 2024;59:468-482. (Among 4628 Japanese adults with inflammatory bowel or Behcet’s disease treated with thiopurines with vs without prior genotyping for NUDT15 and dose adjustment, hepatotoxicity rates were not different [5.6% vs 5.1%] while severe leukopenia rates were less [0.7% vs 5.8%]). 38589597
Zhou Y, Wang L, Sun LR, Zhang L, Wang HM, Liu XT, Yang F, et al. Individualized use of 6-mercaptopurine in Chinese children with ALL: a multicenter randomized controlled trial. Clin Pharmacol Ther. 2024;115:213-220.. (Among Chinese children with ALL treated with chemotherapy with standard doses or genetic based [TMST and NUDY15] modified doses of mercaptopurine, found that the gene-based dosing was associated with lower rates of myelosuppression but similar rates of hepatotoxicity). 37753808
Dongre N, Kalita J, Misra UK. Azathioprine-induced veno-occlusive hepatotoxicity in a patient with myasthenia gravis. Curr Drug Saf. 2025;20:68-73.. (Abstract only: 35 year old man with myasthenia gravis treated with azathioprine for 5 years developed fatigue, abdominal pain, abnormal liver tests, and ultrasound findings suggestive of sinusoidal obstruction syndrome, which resolved after stopping azathioprine). 38265400
van Asseldonk DP, Crouwel F, Seinen ML, Scheffer PG, Veldkamp AI, de Boer NK, Lissenberg-Witte B, et al. Exploring the role of oxidative stress and the effect of N-acetylcysteine in thiopurine-induced liver injury in inflammatory bowel disease: a randomized crossover pilot study. Basic Clin Pharmacol Toxicol. 2024;134:507-518.. (Among 9 patients with inflammatory bowel disease and serum ALT elevations [less than 5 times ULN] during therapy with mercaptopurine [n=7] or azathioprine [n=2] who were continued on the thiopurine and given either N-acetylcysteine [1200 mg twice daily] or placebo for 4 weeks and then crossed-over to the alternative therapy, serum myeloperoxidase levels increased but there were no changes in the liver test abnormalities or levels of thiopurine metabolites). 38284479
Barone T, Dandekar S, McKeone D, Mulieri K. Assessment on the use of allopurinol to improve safety and efficacy of mercaptopurine in pediatric patients with acute lymphoblastic leukemia and lymphoma during maintenance therapy. Cancer Rep (Hoboken). 2024;7:e1987. (Among 15 children with ALL and liver test abnormalities while receiving mercaptopurine who were treated with the addition of allopurinol and decrease in the thiopurine dose, 13 improved although the degree of improvement in liver tests was not provided). 38351548
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 8 [2%] were attributed to azathioprine and 2 [0.9%] to mercaptopurine). 38992407
Güven B, Yıldırım S, Aydın ZGG, İskenderoğlu GPR, Kamaşak T, Çakır M. Drug-induced liver injury in pediatric age group: Single-center experience. Pediatr Int. 2025;67:e70099.. (In a prospective database on drug-induced liver injury among admissions to a referral Turkish medical center between 2021 and 2023, 300 cases were enrolled attributed to 90 different drugs, mercaptopurine being the fifth most frequently implicated agent [n= 32, 5%], most cases being mild and 86% hepatocellular). 40488674
Shi L, Wang Y, Qu Y, Chen R. Hepatotoxicity associated with anti-neoplastic agents: a pharmacovigilance analysis of the Food and Drug Administration Adverse Event Reporting System database. Front Immunol. 2025;16:1665425. (Analysis of reports of hepatotoxicity by antineoplastic agents made to the FDA’s Adverse Event Reporting System [FAERS] between 2004 and 2024 identified 4195 reports of the top 56 agents, mercaptopurine having the highest reporting odds ratio but only 67 reports compared to 766 for methotrexate, 306 rituximab, 245 pembrolizumab, and 188 nivolumab). 41488639

## OTHER REFERENCE LINKS

1. Recent References on Mercaptopurine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mercaptopurine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Mercaptopurine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mercaptopurine)